# Protein Kinase Inhibitors

## OVERVIEW

The kinase inhibitors are a large group of unique and potent antineoplastic agents which specifically target protein kinases that are altered in cancer cells and that account for some of their abnormal growth. Protein kinases are ubiquitous intracellular and cell surface proteins that play critical roles in cell signaling pathways involved in metabolism, injury responses, adaption, growth and differentiation. They act by adding a phosphate group to a protein (phosphorylation), usually on a specific amino acid which often makes the protein or enzyme "active". The human genome has more than 500 protein kinases and they can be classified as (1) tyrosine, (2) serine-theonine or (3) nonspecific (both), based upon their amino acid specificity. Many protein kinases are cell surface receptors and act to initiate an intracellular pathway of activation, after the receptor is engaged by its ligand, typically a cytokine or growth factor. Inhibitors of these kinases are called protein kinase receptor inhibitors. Other kinases are intracellular and take part in cell signaling. These kinases can be targeted by "non-receptor" protein kinases. Finally, some kinase inhibitors have specificity for multiple kinases and are called "multi-kinase inhibitors."

Protein kinases can be specifically involved in cell growth, proliferation and differentiation and mutations may lead to unregulated growth and proliferation that is typical of cancerous cells. These mutated protein kinases represent an attractive target for anticancer agents. The potent activity and lack of generalized toxicity of the kinase inhibitors relate to the specificity of antagonist for the mutated protein. In like manner, their toxicity often relates to off-target activity, either to the unmutated kinase or to closely related, normal kinases.

The protein kinases can be categorized based upon the amino acid that they phosphorylate: either serine, threonine or tyrosine. The tyrosine kinase receptor inhibitors were the initial and are perhaps the best characterized kinase inhibitors. The protein kinase inhibitors are relatively recently developed agents, all having been introduced since 2001. They are unique and represent a major advance in cancer chemotherapy, away from broadly cytotoxic agents and towards drugs that specifically target the molecular abnormalities of cancer cells. The initial tyrosine kinase inhibitor approved for use in the United States was imatinib (Gleevec: 2001) which is used to treat Philadelphia chromosome positive chronic lymphocytic leukemia, which has a mutated kinase receptor (BCR-ABL) that is created by the specific translocation that creates the Philadelphia chromosome. Imatinib is a specific inhibitor of the BCR-ABL kinase. The introduction of this first protein kinase inhibitor was followed by more than a dozen others within the next 10 years.

While most kinase inhibitors are antineoplastic agents, a few are also used for benign conditions including macular degeneration (pegaptanib), rheumatoid arthritis (tofacitinib) and idiopathic pulmonary fibrosis (nintedanib). Generally, however, the side effect profile of kinase inhibitors are such that they are reserved for severe, progressive, debilitating or potentially fatal conditions.

The protein kinase inhibitors all have some degree of hepatotoxicity and many have been linked to cases of clinically apparent liver injury which can be severe and even fatal. Interestingly, some of the cases of liver injury attributed to the protein kinase antagonists had features of autoimmunity, so that the liver injury may be caused by an immunologic reaction to metabolic products of the agent itself, rather than off-target activity of the inhibitor. In addition, at least two protein kinase inhibitors (imatinib and nilotinib) have been linked to instances of reactivation of hepatitis B. It is not clear whether this relates to a specific activity of the kinase inhibitor on hepatitis B virus replication or whether it is due to immunosuppression. Other kinase inhibitors have been linked to cases of rare and idiosyncratic liver injury, which can be hepatocellular or cholestatic and is typically self-limited but may be fatal.

The Table below lists the protein kinase inhibitors discussed in LiverTox, their brand name, predominant protein kinase (PK) specificity, year of approval in the United States, likelihood score, and major clinical uses.

### [underlined: PROTEIN KINASE INHIBITORS]

Underlined Generic Names link to a LiverTox record.

CANCER
Generic Name Brand Name | Kinase Target | Approval | Likelihood Score† | Major Uses††
Abemaciclib Verzenio | Cyclin dependent kinase 4/6 | 2017 | E* | Breast cancer
Acalabrutinib Calquence | Bruton kinase | 2017 | D | Mantel cell lymphoma
Adagrasib Krazati | KRAS | 2022 | D | NSCLC
Afatinib Gilotrif | EGFR, HER2 | 2013 | D | NSCLC
Alectinib Alecensa | ALK | 2015 | D | NSCLC
Alpelisib Piqray | PIK3 | 2019 | E* | Breast cancer, HR positive, HER2 negative
Asciminib Scemblix | ABL1 Myristoyl | 2021 | E* | CML
Avapritinib Ayvakit | PDGFRA, KIT | 2020 | E* | Gastrointestinal stromal tumors
Axitinib Inlyta | VEGFR 1-3 | 2012 | E* | Renal cell cancer
Binimetinib Mektovi | BRAF | 2018 | E* | Melanoma
Bortezomib Velcade | Proteasome | 2003 | C | Multiple myeloma, Mantle cell lymphoma
Bosutinib Bosulif | BCR-ABL, scr | 2012 | D | CML, resistant
Brigatinib Alunbrig | ALK | 2017 | E* | NSCLC
Cabozantinib Cometriq, Cabometyx | MET, VEGFR-2 | 2012 | E* | Medullary thyroid cancer, Renal cell cancer
Capivasertib Truqap | AKT1, AKT2, AKT3 | 2023 | E* | Breast cancer
Capmatinib Tabrecta | MET | 2020 | E* | NSCLC
Carfilzomib Kyprolis | Proteasome | 2012 | D | Multiple myeloma, resistant
Ceritinib Zykadia | ALK | 2014 | D | NSCLC
Cobimetinib Cotellic | MEK | 2015 | D | Melanoma
Copanlisib Aliqopa | PI3Kα/δ | 2017 | E* | Follicular lymphoma
Crizotinib Xalkori | ALK | 2011 | C | NSCLC
Dabrafenib Tafinlar | BRAF | 2013 | E* | Melanoma
Dacomitinib Vizimpro | HER1,2,3 | 2018 | E* | NSCLC
Dasatinib Sprycel | BCR-ABL, src | 2006 | D | CML, resistant
Duvelisib Copiktra | PI3K | 2018 | E* | CLL, Small cell lymphoma
Enasidenib IDHIFA | Mutant IDH-2 | 2017 | E* | AML
Encorafenib Braftovi | BRAF | 2018 | E* | Melanoma
Ensartinib Ensacove | ALK | 2024 | D* | NSCLC
Entrectinib Rozlytrek | NTRK, ROS1 | 2019 | E* | NSCLC
Erdafitinib Balversa | FGFR | 2019 | E* | Urothelial cancer
Erlotinib Tarceva | EGFR, HER1 | 2004 | B | NSCLC, Pancreatic cancer
Fedratinib Inrebic | JAK-2 | 2019 | D | Myelofibrosis
Fruquintinib Fruzaqla | VEGF | 2023 | E* | Colorectal cancer
Futibatinib Lytgobi | FGFR | 2022 | E* | Cholangiocarcinoma
Gefitinib Iressa | EGFR | 2009 | B | NSCLC
Gilteritinib Xospata | FLT3 | 2018 | E* | AML
Glasdegib Daurismo | Hedgehog | 2018 | E* | AML
Ibrutinib Imbruvica | Bruton kinase | 2013 | D | Mantle cell lymphoma, CLL
Idelalisib Zydelig | PI3Kδ | 2014 | D | CLL, Non-Hodgkin lymphoma
Imatinib Gleevec | BCR-ABL, c-Kit | 2001 | B | CML, GIST
Inavolisib Itovebi | PIK3 | 2024 | E* | Breast cancer
Infigratinib Truseltiq | FGFR | 2021 | E* | Cholangiocarcinoma
Ivosidenib Tibsovo | Mutant IDH-1 | 2018 | E* | AML
Ixazomib Ninlaro | 26S Proteasome | 2015 | E* | Multiple myeloma
Lapatinib Tykerb | EGFR, HER2 | 2007 | B | Breast cancer, HER2 positive
Larotrectinib Vitrakvi | NTRK | 2018 | E* | Solid tumors
Lazertinib Lazcluze | EGF | 2024 | E* | Non-small cell lung cancer
Lenvatinib Lenvima | VEGFR 1-3, FGF 1-4, PDGF, c-Kit, RET | 2015 2016 2018 | D | Thyroid cancer Renal cell cancer Hepatocellular cancer
Lorlatinib Lorbrena | ALK | 2018 | E* | NSCLC
Midostaurin Rydapt | FLT3 | 2018 | E* | AML
Mobocertinib Exkivity | EGFR exon 20 | 2021 | E* | NSCLC
Momelotinib Ojjaara | JAK-1/2 | 2023 | D | Myelofibrosis
Neratinib Nerlynx | HER2 | 2017 | E* | Breast cancer
Nilotinib Tasigna | BCR-ABL | 2007 | D | CML, resistant
Niraparib Zejula | PARP | 2017 | E* | Ovarian cancer
Olaparib Lynparza | PARP | 2014 2018 | E | Ovarian cancer Advanced breast cancer
Olutasidenib Rezlidhia | Mutant IDH-1 | 2022 | D | AML
Osimertinib Tagrisso | EGFR | 2015 | E* | NSCLC, refractory
Pacritinib Vonjo | JAK2, FLT3 | 2023 | E* | Myelofibrosis
Palbociclib Ibrance | ER+, HER2 | 2015 | C | Breast cancer, HER2 negative
Pazopanib Votrient | VEGFR 1-3 | 2009 | C | Renal cell cancer
Pemigatinib Pemazyre | FGFR | 2020 | E* | Cholangiocarcinoma Myeloid or lymphoid neoplasms
Pexidartinib Turalio | CSF1, FLT3 | 2019 | B | Tenosynovial giant cell tumor
Pirtobrutinib Jaypirca | Bruton kinase | 2023 | E* | Mantel cell lymphoma CLL, Small cell lymphoma
Ponatinib Iclusig | BCR-ABL | 2013 | E* | CML, ALL
Pralsetinib Gavreto | RET | 2020 – Accel.; 2023 | E* | NSCLC, Thyroid cancer
Quizartinib Vanflyta | FLT3 | 2023 | E | AML
Regorafenib Stivarga | VEGFR 1-3, PDGF | 2012 | B | Colorectal cancer, GIST
Repotrectinib Augtyro | ROS1, TRKA, B, C | 2023 | E* | NSCLC
Revumenib Revuforj | Menin | 2024 | E* | Leukemia
Ribociclib Kisqali | Cyclin dependent kinase 4/6 | 2017 | C | Breast cancer
Ripretinib Qinlock | PDGFRA, KIT | 2020 | E | Gastrointestinal stromal tumors
Rucaparib Rubraca | PARP | 2016 | E* | Ovarian cancer, advanced
Ruxolitinib Jakafi | JAK-1/2 | 2011; 2014; 2019 | C | Myelofibrosis; Polycythemia vera; Acute graft-vs-host disease, steroid-resistant
Selpercatinib Retevmo | RET | 2020 – 2022 | E* | NSCLC, Thyroid Cancer [2020 Accel., 2022 NSCLC Approval]; Solid Tumors; [2022 Accel.]
Selumetinib Koselugo | MEK 1/2 | 2020 | E* | Neurofibromatosis type 1
Sonidegib Odomzo | Hedgehog | 2015 | E* | Basal cell skin cancer
Sorafenib Nexavar | VEGFR 1-3 | 2005 2007 2013 | B | Renal cell cancer Hepatocellular cancer Thyroid cancer
Sotorasib Lumakras | KRAS | 2019 | D | NSCLC
Sunitinib Sutent | PDGF, c-Kit | 2006 | B | CML, resistant; GIST, renal cell cancer
Talazoparib Talzenna | PARP | 2018 | E* | Breast cancer
Tepotinib Tepmetko | MET | 2021 | E* | NSCLC
Tivozanib Fotivda | VEGFR-1,2,3, c-kit, PDGFR-β | 2021 | E* | Renal cell cancer
Tovorafenib Ojemda | BRAF | 2024 | E* | Glioma
Trametinib Mekinist | MEK 1/2 | 2013 | E* | Melanoma
Trilaciblib Cosela | Cyclin dependent kinase 4/6 | 2021 | E | Prevention of chemotherapy-induced myelosuppression in SCLC
Tucatinib Tukysa | HER2 | 2020 2023 | E* | Breast cancer Colorectal cancer
Umbralisib Ukoniq | PI3Kδ | 2021 | E* | Follicular lymphoma
Vandetanib Caprelsa | VEGFR 2 | 2011 | E* | Medullary thyroid cancer
Vemurafenib Zelboraf | BRAF | 2011 | E* | Melanoma
Vismodegib Erivedge | Hedgehog | 2012 | C | Basal cell skin cancer
Zanubrutinib Brukinsa | BTK | 2019 | E* | Mantel cell lymphoma
MISCELLANEOUS
Generic Name Brand Name | Kinase Target | Approval | Likelihood Score† | Major Uses††
Abrocitinib Cibinqo | Janus kinase 1 | 2022 | E | Atopic dermatitis
Baricitinib Olumiant | Janus kinase | 2018; 2022 | E* | Rheumatoid arthritis; Alopecia areata
Belumosudil Rezurock | ROCK | 2021 | E | Graft-versus-host disease
Deucravacitinib Sotyktu | Tyrosine kinase 2 | 2023 | E | Plaque psoriasis
Deuruxolitinib Leqselvi | Janus kinase | 2024 | E* | Alopecia areata
Fostamatinib Tavalisse | Spleen tyrosine kinase | 2017 | E* | Immune thrombocytopenia
Leniolisib Joenja | PI3Kδ | 2023 | E | Activated PI3K-delta Syndrome
Lonafarnib Zokinvy | FTase | 2020 | E* | Progeria syndrome
Nintedanib Ofev | VEGFR, FGFR, PDGFR | 2014 | E* | Pulmonary fibrosis
Pegaptanib Macugen | VEGFR 1-3 | 2004 | E | Macular degeneration
Ritlecitinib Litfulo | Janus kinase 3 | 2023 | E* | Alopecia areata
Tofacitinib Xeljanz | Janus kinase | 2012; 2017; 2018 | E* | Rheumatoid arthritis; Psoriatic arthritis; Ulcerative colitis
Upadacitinib Rinvoq | Janus kinase | 2019 | D | Rheumatoid arthritis

† Likelihood Score indicates the likelihood of association with drug induced liver injury, based upon the known potential of the drug to cause such injury.

†† Abbreviations: ALL, acute lymphocytic leukemia; AML, acute myeloid leukemia; CLL, chronic lymphocytic leukemia; CML, chronic myelogenous leukemia; GIST, gastrointestinal stromal tumor; NSCLC, non-small cell lung cancer.